# Cimetidine

## OVERVIEW

### Introduction

Cimetidine is a histamine type 2 receptor antagonist (H2 blocker) which is widely used for treatment of acid-peptic disease and heartburn. Cimetidine has been linked to rare instances of clinically apparent acute liver injury.

### Background

Cimetidine (sye met' i deen) was the first H2 blocker introduced into clinical practice in the United States and remains a commonly used agent for treatment of duodenal and gastric ulcer and gastroesophageal reflux disease. The H2 blockers are specific antagonists of the histamine type 2 receptor, which is found on the basolateral (antiluminal) membrane of gastric parietal cells. The binding of cimetidine to the H2 receptor results in inhibition of acid production and secretion, and improvement in symptoms and signs of acid-peptic disease. The H2 blockers inhibit an early, “upstream” step in gastric acid production and are less potent that the proton pump inhibitors, which inhibit the final common step in acid secretion. Nevertheless, the H2 blockers inhibit 24 hour gastric acid production by about 70% and are most effective in blocking basal and nocturnal acid production. Cimetidine was first approved for use in the United States in 1977 and is still used widely both by prescription and in over-the-counter forms. The listed indications for cimetidine include duodenal and gastric ulcer disease, gastroesophageal reflux and prevention of stress ulcers. Cimetidine is available by prescription in tablets of 200, 300, 400 and 800 mg in several generic forms and in both oral and parenteral forms under the brand name Tagamet. Over-the-counter preparations are usually tablets of 200 mg. The typical recommended dose of cimetidine for peptic ulcer disease in adults is 300 to 400 mg twice daily or 800 mg at night for up to 8 weeks, and maintenance doses of 400 mg once daily. Lower chronic or intermittent doses are commonly used to treat heartburn and indigestion. Side effects are uncommon, usually minor, and include diarrhea, constipation, fatigue, drowsiness, headache and muscle aches. Cimetidine is metabolized by and can inhibit several isoforms of the hepatic cytochrome P450 system (CYP 1A2, 2C9 and 2D6), which can result in significant drug-drug interactions if administered with agents that rely upon their metabolism by these microsomal enzymes (such as digoxin, warfarin, oral contraceptives, isoniazid and phenytoin).

### Hepatotoxicity

Chronic therapy with cimetidine has been associated with minor elevations in serum aminotransferase levels in 1% to 4% of patients, but similar rates were reported in placebo recipients. The ALT elevations were usually asymptomatic and transient and usually resolved even without dose modification. Several instances of clinically apparent liver injury have been reported in patients receiving cimetidine, but the time to onset and pattern of injury has varied greatly. Onset can be as short as a few days to as long as 7 months, and the serum enzyme pattern varies from hepatocellular to cholestatic, most cases having a “mixed” hepatocellular-cholestatic pattern of injury (Cases 1 and 2). The injury is rarely severe and resolves within 4 to 12 weeks of stopping cimetidine. Liver biopsy histology often shows prominent centrolobular necrosis. Immunoallergic features (rash, fever, eosinophilia) are uncommon, as is autoantibody formation.

Likelihood score: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Injury

Cimetidine is metabolized by and inhibits the function of the microsomal P450 drug metabolizing enzymes, and injury may be the result of its activation to a toxic intermediate. Rapid recurrence with rechallenge is typical, but features of hypersensitivity are uncommon.

### Outcome and Management

The hepatic injury caused by cimetidine is usually rapidly reversible with stopping the medication (Case 1). Cimetidine has not been definitively linked to cases of acute liver failure, but there has been at least one case of prolonged cholestasis with probable vanishing bile duct syndrome after an episode of cholestatic hepatitis attributed to cimetidine. Rechallenge usually causes recurrence which can be more severe than the initial episode. There appears to be little cross susceptibility to hepatic injury between ranitidine and cimetidine, but instances have been reported of recurrence after famotidine (Case 2). If acid suppression is required, use of an unrelated proton pump inhibitor is probably prudent for patients with clinically apparent cimetidine induced liver injury.

The H2 receptor blockers include cimetidine, famotidine, nizatidine, and ranitidine. General references on all four agents are given together after the overview section on H2 Blockers, while specific references are given with the description of each drug. See also the Proton Pump Inhibitors.

Drug Class: Antiulcer Agents

Other Drugs in the Subclass, Histamine Type 2 Receptor Antagonists/H2 Blockers: Famotidine, Nizatidine, Ranitidine

## CASE REPORTS

### Case 1. Mild acute liver injury due to cimetidine.

[Modified from: Ruiz Del Arbol L, Moreira V, Moreno A, Hernández Ranz F, Cano A, García Plaza A. Bridging hepatic necrosis associated with cimetidine. Am J Gastroenterol 1980; 74: 267-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/7468564)]

A 67 year old man with gastroesophageal reflux disease (GERD) was found to have abnormal liver tests 7 months after starting cimetidine (400 mg daily). He felt well and denied fatigue, abdominal pain or jaundice. Laboratory tests showed elevations in serum aminotransferase and alkaline phosphatase levels and a total serum bilirubin of 2.0 mg/dL (Table). Tests for hepatitis B were negative. Cimetidine was stopped and he was switched to oral antacids. Serum enzyme levels fell into the normal range within two weeks, but because of worsening reflux symptoms, cimetidine was restarted. He rapidly redeveloped serum laboratory abnormalities, and cimetidine was again stopped. Because of his severe reflux symptoms, he underwent surgery two weeks later, at which time a liver biopsy was done which showed centrolobular (zone 3) necrosis with areas of collapse and bridging fibrosis, with only mild residual inflammation. In follow up, he was asymptomatic and serum enzymes were normal.

#### Key Points

Medication: | Cimetidine (200 mg daily)
Pattern: | Mixed (R=2.4)
Severity: | 1+ (enzyme elevation without jaundice or symptoms)
Latency: | 7 months initially, 2 weeks upon rechallenge
Recovery: | ~10 weeks initially, 2 weeks upon rechallenge
Other medications: | Antacids

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Cimetidine therapy for GERD
7 months | 0 | 246 | 216 | 2.0 | Cimetidine stopped
9 months | 2 months | 71 | 104 | 1.4
10 months | 3 months | 32 | 86 | 0.8
| | Cimetidine restarted
2 weeks | 0 | 175 | 210 | 2.3 | Cimetidine stopped
4 weeks | 2 weeks | 28 | 79 | 1.0
9 months | 8 months | 14 | 80 | 0.9
Normal Values | | <45 | <90 | <1.2

#### Comment

This patient developed a mild, anicteric hepatitis with a "mixed" pattern of serum enzyme elevations, which was first discovered 7 months after he had started cimetidine therapy for gastroesophageal reflux. He recovered upon withdrawal of cimetidine, but his reflux symptoms led to cimetidine being restarted, whereupon the hepatitis recurred. Interestingly, the pattern of serum enzyme elevations and mild increase in bilirubin levels were identical upon reexposure, but the latency to onset and the time to recovery were more rapid. A liver biopsy showed centrolobular necrosis which is typical of cimetidine induced hepatic injury.

### Case 2. Acute hepatitis attributed to cimetidine.

[Modified from: Zaidenstein R, Cohen N, Golik A. [Cimetidine hepatitis]. Harefuah 1992; 123: 516-8, 572. Hebrew. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/1289197)]

A 41 year old man with rheumatoid arthritis and active duodenal ulcer disease developed jaundice within 3 days of starting intravenous cimetidine (400 mg twice daily). He had been admitted from the emergency room with stable vital signs, but pallor and hemoglobin of 5.1 g/dL, and stabilized with fluids and 4 units of packed red blood cells. Serum enzymes were normal on the first admission day shortly after cimetidine was started. By day three of intravenous therapy, however, serum bilirubin was 19.4 mg/dL, ALT 1000 U/L, and alkaline phosphatase 200 U/L. In addition, LDH levels were markedly elevated on day three (2760 U/L), having been only minimally elevated one day before (415 U/L). Tests for hepatitis A and B were negative, and abdominal ultrasound showed no evidence of gallstones or biliary obstruction. A liver biopsy was not done. Liver tests improved almost as rapidly as they became abnormal and were back to baseline within 2 weeks.

#### Key Points

Medication: | Cimetidine (400 mg intravenously twice daily)
Pattern: | Hepatocellular (R=~12)
Severity: | 3+ (jaundice and hospitalization prolonged)
Latency: | 3 days
Recovery: | 2 weeks
Other medications: | Occasional aspirin and indomethacin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Admitted for UGI bleeding and started on cimetidine
1 day | | 7 | 93
3 days | 0 | 1000 | 200 | 19.4 | Cimetidine stopped
4 days | 1 day | 960 | 202 | 7.4
5 days | 4 days | 740 | 283 | 8.0
8 days | 7 d ays | 184 | 462 | 3.1
2 weeks | 13 days | 44 | 202 | 1.1
Normal Values* | | <45 | <115 | <1.2

* Normal range not provided.

#### Comment

This patient developed jaundice within days of starting intravenous cimetidine. The clinical pattern was acute hepatic necrosis, with rapid and precipitous onset, high peak serum aminotransferase and LDH levels, and rapid recovery upon withdrawal of the agent. The precipitous nature of this example may have been due to the intravenous administration of cimetidine. Another possibility is that the injury was due to ischemic hepatitis caused by an unobserved episode of hypotension (the patient was admitted with suspected upper gastrointestinal bleed with a hemoglobin level of only 5.1 g/dL) and that the blood transfusions contributed to the rapid onset of jaundice.

### Case 3. Acute liver injury due to famotidine and recurrence due to cimetidine.

[Modified from: Hashimoto F, Davis RL, Egli D. Hepatitis following treatments with famotidine and then cimetidine. Ann Pharmacother 1994; 28: 37-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/8123956)]

A 51 year old woman with symptomatic duodenal ulcer disease was treated with famotidine (40 mg daily), with subsequent improvement in epigastric pain and nausea, but with reappearance of abdominal discomfort followed by dark urine, itching and jaundice starting 3 weeks later. She denied fever or rash or history of drug allergy. She was overweight (BMI=34.1), but had lost 2.3 kilograms in the previous week. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. On examination, she was jaundiced and had mild hepatic tenderness but no peripheral signs of chronic liver disease. Laboratory testing showed total bilirubin of 5.0 (direct 4.1) mg/dL, ALT 661 U/L, alkaline phosphatase 193 U/L, with normal serum albumin and prothrombin time (Table). Tests for hepatitis A, B and C were negative as were autoantibodies. Abdominal ultrasound showed an echogenic liver suggestive of steatosis, but no signs of biliary obstruction. Famotidine was stopped and omeprazole (20 mg daily) substituted. She improved rapidly and liver tests were normal or near normal 5 weeks later, at which point cimetidine (800 mg daily) was substituted for omeprazole. One week later she redeveloped abdominal pain and nausea. The dose of cimetidine was increased, but over the next week she developed worsening symptoms and dark urine. Laboratory testing showed rises in serum bilirubin, ALT and alkaline phosphatase similar to those after famotidine therapy and cimetidine was stopped. Repeat evaluation revealed no evidence of viral hepatitis, autoimmune liver disease or biliary obstruction. She improved and was maintained on omeprazole therapy for her acid-peptic disease. In follow up 6 weeks later, liver tests had returned to normal or near normal levels.

#### Key Points

Medication: | Famotidine (40 mg daily), Cimetidine (800 and 1200 mg daily)
Pattern: | Hepatocellular (R=14)
Severity: | 3 (jaundice, hospitalization)
Latency: | 3-4 weeks for famotidine, 1-2 weeks for cimetidine
Recovery: | 6 weeks
Other medications: | Antacids, occasional acetaminophen, oral contraceptives (many years)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Famotidine (40 mg/day) started
4 weeks | 0 | 661 | 193 | 5.0 | Famotidine stopped
5 weeks | 1 week | 250 | 250 | 1.5 | Symptoms resolved
6 weeks | 2 weeks | 120 | 150 | 1.0
9 weeks | 5 weeks | 55 | | | Cimetidine started
11 [2] weeks | 7 [0] weeks | 590 | 180 | 4.4 | Cimetidine stopped
12 [3] weeks | [1] week | 430 | 320 | 8.2
13 [4] weeks | [2] weeks | 190 | 210 | 1.2
14 [5] weeks | [3] weeks | 90 | 180
16 [7] weeks | [5] weeks | 48 | 120 | 1.0
18 [9] weeks | [7] weeks | 44 | 60
Normal Values | | <35 | <150 | <1.2

* Some values estimated from Figure 1, and bilirubin levels converted from µmol to mg/dL. Weeks [in brackets] represent time after starting or stopping cimetidine.

#### Comment

This patient appeared to develop a transient and self-limiting acute hepatitis-like injury after both famotidine and cimetidine therapy. The cross reactivity of these two agents was not suspected, based upon the lack of such cross reactivity to hepatic injury between cimetidine and ranitidine. However, in the case shown above, the recurrence was more rapid and perhaps slightly more severe with the “re-exposure” using cimetidine. Typical of H2 receptor blocker induced liver injury was the rapid recovery upon withdrawal. While liver biopsy was not done, in most such instances centrolobular necrosis with inflammation and mild cholestasis is found. This patient may have had mild underlying nonalcoholic fatty liver disease, but this is a common medical condition and probably did not play a role in the clinically apparent liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cimetidine – Generic, Tagamet®

DRUG CLASS

Antiulcer Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cimetidine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cimetidine | 51481-61-9 | C10-H16-N6-S | Cimetidine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 January 2018

Zimmerman HJ. H2 Receptors antagonists. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 719-20. (Expert review of hepatotoxicity published in 1999 states that cimetidine and ranitidine, despite extensive use, have been implicated in only a small number of cases of hepatic injury, 39 for cimetidine, 35 for ranitidine and 1 for famotidine, all cases recovering and signs of hypersensitivity being rare).
Wallace JL, Sharkey KA. Pharmacotherapy of gastric acidity, peptic ulcers, and gastroesophageal reflux disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman.s the pharmacological basis of therapeutics. 121th ed. New York: McGraw-Hill, 2011, pp. 1309-1322. (Textbook of pharmacology and therapeutics).
Züchner H. [Cholestatic hepatitis under Cimetidine]. Dtsch Med Wochenschr 1977; 102: 1788-9. German. (57 year old developed anorexia 2 days after starting cimetidine followed by jaundice [bilirubin 9.8 mg/dL, ALT 487 U/L, Alk P 1600 U/L], rapid resolution on stopping, and recurrence on rechallenge with bilirubin rising to 5.9 mg/dL, ALT 330 U/L, Alk P 528 U/L, biopsy showing intrahepatic cholestasis). 923468
Bodemar G, Walan A. Maintenance treatment of recurrent peptic ulcer by cimetidine. Lancet 1978; 311: 403-7. (Controlled trial of 1 year course of cimetidine vs placebo in 68 patients with recurrent ulcer disease; ALT >3 times ULN occurred in 12% of cimetidine- vs 3% of placebo-recipients, 2 liver biopsies showed centrilobular necrosis; all resolved upon stopping; no bilirubin or other values given). 75439
Lilly JR, Hitch DC, Javitt NB. Cimetidine cholestatic jaundice in children. J Surg Res 1978; 24: 384-7. (5 children with ulcer disease were monitored closely during 13-76 days of iv and oral cimetidine therapy [20-30 mg/k/day, all had increases in serum bile acids and 3 had bilirubin elevations [peak 1.8-2.9 mg/dL], but without changes in ALT or Alk P; all resolved on or after stopping therapy and most had underlying conditions such as biliary atresia, short bowel syndrome, gastric outlet obstruction). 651333
Kruss DM, Littman A. Safety of cimetidine. Gastroenterology 1978; 74 (2 Pt 2): 478-83. (Review of the safety of cimetidine from registration trials; in European trials liver test elevations were similar with cimetidine [n=1280] as placebo [n=481] and in 4 with marked elevations, levels resolved without dose modification, biopsy in 2 showing centrolobular necrosis; in US trials, mean AST values were the same in cimetidine- as placebo-recipients, minor single elevations occurred in ~50% of patients; all 29 cases with AST >100 U/L resolved rapidly or were due to other conditions; a single case of fulminant hepatitis occurred in a placebo recipient). 620916
Villeneuve JP, Warner HA. Cimetidine hepatitis. Gastroenterology 1979; 77: 143-4. (83 year old developed jaundice 4 months after a blood transfusion and starting cimetidine [bilirubin 15 mg/dL, AST 935 U/L, Alk P 160 U/L], with resolution within 4 weeks and recurrence within 1 month of restarting [bilirubin 6.5 mg/dL, AST 189 U/L, Alk P 171 U/L], and again within 2 days of deliberate rechallenge [bilirubin 1.4 mg/dL, AST 1150 U/L, Alk P 123 U/L). 447012
Berthelot P. Cimetidine hepatitis. Gastroenterology 1979; 77: 1365-6. (Letter in response to Villeneuve [1979] mentioning the earlier report by Zuchner of cholestatic hepatitis after use of cimetidine). 499722
Glade G, Saccar CL, Pereira GR. Cimetidine in pregnancy: apparent transient liver impairment in the newborn. Am J Dis Child 1980; 134: 87-8. (Small birth weight infant born to mother on cimetidine had prolonged jaundice with peak bilirubin 10 mg/dL, ALT 115 U/L, Alk P 48 at 4 days of age, resolving by 6 weeks; hypothesized that cimetidine which passes the placenta may have caused the injury). 7188656
Ruiz Del Arbol L, Moreira V, Moreno A, Hernández Ranz F, Cano A, García Plaza A. Bridging hepatic necrosis associated with cimetidine. Am J Gastroenterol 1980; 74: 267-9. (67 year old developed elevations in liver tests 7 months after starting cimetidine [bilirubin 2 mg/dL, ALT 246 U/L, Alk P 216 U/L], which returned to normal 3 months later with positive rechallenge during which liver biopsy showed centrozonal necrosis with occasional bridging: Case 1). 7468564
Lorenzini I, Jezequel AM, Orlandi F. Cimetidine-induced hepatitis. Electron microscopic observations and clinical pattern of liver injury. Dig Dis Sci 1981; 26: 275-80. (36 year old developed jaundice 2.5 months after starting cimetidine [bilirubin 3.2 mg/dL, ALT 407 U/L, Alk P 192 U/L, eosinophils normal]; biopsy showing focal necrosis and inflammation, rapid recovery [1 week], positive rechallenge in 4 days [ALT 4 times ULN]). 7238251
Sawyer D, Conner CS, Scalley R. Cimetidine: adverse reactions and acute toxicity. Am J Hosp Pharm 1981; 38: 188-97. (Review of adverse reactions to cimetidine; in registration studies, ALT elevations occurred in 3.6% of cimetidine- and 4.4% of placebo-recipients and specific review of those with AST >100 U/L found none to be severe; 3 case reports of clinically apparent liver injury, 2 with positive rechallenge; likely due to hypersensitivity). 7011006
Delpre G, Kadish U, Livni E. Hepatitis following cimetidine administration. Am J Med Sci 1982; 283: 153-6. (67 year old had elevations in AST [150 U/L], Alk P [126 U/L], and bilirubin [1.2 mg/dL] 7 months after starting cimetidine, but was also on mesterolone; macrophage inhibitor factor assays were reactive to cimetidine but not mesterolone; cimetidine was stopped but follow up was incomplete). 7081289
Freston JW. Cimetidine: II. Adverse reactions and patterns of use. Ann Intern Med 1982; 97: 728-34. (Review of side effects of cimetidine; diarrhea, nausea, rash and headache [<1% each]; hepatitis rare but described, all being reversible). 6753681
Porter JB, Jick H, Perera DR, Ylvisaker JT, Hunter JR. Long-term follow-up study of cimetidine. Pharmacotherapy 1984; 4: 381-4. (Analysis of side effects from 5 year follow up of 8553 patients who received at least one prescription for cimetidine in a Seattle HMO found 26 patients who were hospitalized for a possible complication of therapy but only one was possibly linked to cimetidine use). 6514588
Jean-Pastor MJ, Jouglard J. [Evaluation of drug-induced hepatic complications collected by the French drug surveillance organization] Therapie 1984; 39: 493-500. French. (Among 980 cases of drug induced liver injury analyzed by the French drug surveillance system, 6 were attributed to cimetidine and considered "plausible"). 6506005
Van Steenbergen W, Vanstapel MJ, Desmet V, Van Kerckvoorde L, De Keyzer R, Brijs R, Fevery J, et al. Cimetidine-induced liver injury. Report of three cases. J Hepatol 1985; 1: 359-68. (3 cases of cimetidine induced liver injury: ages 58-74 years, onset in 7-20 days, ALT 70-392 U/L, Alk P 163-381 U/L, bilirubin normal to 23.2 mg/dL, one with liver failure, two with rapid recovery upon stopping). 4056348
Souza Lima MA. Ranitidine and hepatic injury. Ann Intern Med 1986; 105: 140. (Reviewed reports to FDA on liver injury due to ranitidine, finding 18 convincing cases compared to only 3 for cimetidine; latency of days to 2 months; all recovered). 3717793
Dobbs JH, Muir JG, Smith RN. H2-antagonists and hepatitis. Ann Intern Med 1986; 105: 803. (Letter in response to Souza Lima [1986]; in comparative registration trials, hepatitis developed in 1 of 1786 patients on ranitidine vs 1 of 1743 on cimetidine. In controlled trials of ranitidine in 2332 patients, 2 developed hepatitis [~0.08%]. All recovered upon withdrawal). 3767169
Schwartz JT, Gyorkey F, Graham DY. Cimetidine hepatitis. J Clin Gastroenterol 1986; 8: 681-6. (62 year old developed rising ALT [83 to 520 to 700 U/L] between 9 and 12 weeks after starting cimetidine [biopsy showing centrolobular necrosis], with prompt improvement on stopping and positive rechallenges at both high [100 mg] and low [300 mg] doses; serum bilirubin and Alk P not provided). 3805669
Black M. Hepatotoxic and hepatoprotective potential of histamine (H2)-receptor antagonists. Am J Med 1987; 83: 68-75. (Review of hepatotoxicity of cimetidine and ranitidine and their potential role in ameliorating acetaminophen hepatotoxicity, perhaps via their inhibition of P450 activity). 2892410
Clarke B, Yoong A. Prolonged cholestasis and cimetidine. Dig Dis Sci 1987; 32: 333. (45 year old developed prolonged jaundice and cholestasis after 5 days of cimetidine therapy which was promptly stopped, bilirubin rising to 24.8 mg/dL ALT 44 U/L, Alk P 980 U/L, GGT 64 U/L, and biopsy showing intrahepatic cholestasis; mild jaundice was still present 9 months later; no mention of bile duct injury or paucity on biopsy). 3816488
Lewis JH. Hepatic effects of drugs used in the treatment of peptic ulcer disease. Am J Gastroenterol 1987; 82: 987-1003. (Thorough review of hepatotoxicity of antiulcer medications; 10 published cases of hepatotoxicity due to cimetidine and 12 for ranitidine, none fatal and not all convincingly due to the medication; little information available on famotidine or nizatidine). 2889354
Vázquez Arnedo M, Pastor Fanco A, Bestue Fuster JM. [Cimetidine and toxic hepatitis]. Rev Esp Enferm Apar Dig 1987; 71: 66-8. Spanish. (38 year old with duodenal ulcer disease developed fatigue 45 days and jaundice 82 days after starting cimetidine [bilirubin 14.4 mg/dL, ALT 978 U/L, Alk P 169 U/L], with rapid improvement on stopping and no recurrence upon starting ranitidine). 3563038
Kadri AZ, Fisher R, Winterton MC. Cimetidine and paracetamol hepatotoxicity. Hum Toxicol 1988; 7: 205. (56 year old woman on long term cimetidine therapy [400 mg/day] took acetaminophen overdose [~16 g] and presented with high plasma levels and severe metabolic acidosis, but no elevations in ALT, Alk P or bilirubin, possibly because of cimetidine effect on acetaminophen metabolism through P450 system). 3378811
Kimura H, Akamatsu K, Sakaue H, Nogawa M, Ohta Y. Fulminant hepatitis induced by cimetidine. J Gastroenterol Hepatol 1988; 3: 223-6. Not in PubMed (44 year old presented with acute liver failure one year after starting long-term cimetidine [bilirubin 19 mg/dL, ALT 234 U/L, Alk P 286 U/L, prothrombin index 40%], with hepatic encephalopathy but ultimate recovery; 1 year later, she developed nausea, ALT 297 U/L, Alk P 378 U/L one month after restarting cimetidine with rapid recovery on stopping]).
Boyd PT, Lepre F, Dickey JD. Chronic active hepatitis associated with cimetidine. BMJ 1989; 298: 324-5. (32 year old woman developed jaundice 6 months after starting cimetidine [bilirubin 5.8 mg/dL, Alk P 167 U/L, AST 1542 U/L, protime 32 sec], resolving 10 weeks later and positive severe rechallenge within 1 week of restarting; liver biopsy was interpreted as showing chronic active hepatitis and prednisone given). 2493922
Zaidenstein R, Cohen N, Golik A. [Cimetidine hepatitis]. Harefuah 1992; 123: 516-8, 572. Hebrew. (41 year old man developed jaundice 3 days after starting intravenous cimetidine [bilirubin 19.4 mg/dL, ALT 1000 U/L, Alk P 200 U/L, LDH 2760 U/L], recovering rapidly upon stopping: Case 2). 1289197
Polunina TE, Fomichev VI, Vasil'ev AP. [Acute drug-induced hepatitis in a patient with peptic ulcer]. Klin Med (Mosk) 1992; 70: 102-3. Russian. (41 year old man developed jaundice 3 days after starting intravenous cimetidine [bilirubin 19.4 mg/dL, ALT 1000 U/L, Alk P 200 U/L, LDH 2760 U/L], biopsy not done, recovery within 2 weeks of stopping). 1507799
Hashimoto F, Davis RL, Egli D. Hepatitis following treatments with famotidine and then cimetidine. Ann Pharmacother 1994; 28: 37-9. (51 year old woman developed pain and jaundice 3-4 weeks after starting famotidine [bilirubin 5 mg/dL, ALT 661 U/L, Alk P 193 U/L], recovering rapidly on omeprazole but with recurrence 1 week after starting cimetidine [bilirubin 8 mg/dL, ALT ~590 U/L, Alk P ~320 U/L], with rapid improvement on switching again to omeprazole: Case 3). 8123956
García Rodríguez LA, Ruigómez A, Jick H. A review of epidemiologic research on drug-induced acute liver injury using the general practice research data base in the United Kingdom. Pharmacotherapy 1997; 17: 721-8. (Combined analysis of 8 epidemiologic studies using the UK General Practice Research Database estimated incidence rates of acute liver injury to be highest for isoniazid and chlorpromazine [4 and 1.3 per 1000 users], intermediate for amoxicillin-clavulanate, cimetidine and ranitidine [2.3, 2.3 and 0.9 per 10,000], and lowest for TMP/SMZ, omeprazole, amoxicillin and nonsteroidals [5.2, 4.3, 3.9 and 3.7 per 100,000]). 9250549
García Rodríguez LA, Wallander MA, Stricker BH. The risk of acute liver injury associated with cimetidine and other acid-suppressing anti-ulcer drugs. Br J Clin Pharmacol 1997; 43: 183-8. (Case control study in cohort of 100,000 users of antiulcer drugs in a UK general practice database; 33 cases of acute liver injury found, 12 on cimetidine for a relative risk [RR] of 5.5, 1 on omeprazole and 5 on ranitidine did not raise RR above baseline. Latency was <2 month in 80% of cases; most antiulcer drug cases had hepatocellular or mixed enzyme patterns [15 of 18]). 9131951
Fisher AA, Le Couteur DG. Nephrotoxicity and hepatotoxicity of histamine H2 receptor antagonists. Drug Saf 2001; 24: 39-57. (Review of renal and hepatic complications of H2 blocker therapy). 11219486
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to an H2 blocker or proton pump inhibitor). 15390328
de Abajo FJ, Montero D, Madurga M, García Rodríguez LA. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. (Analysis of General Practice Research Database from UK on 1.6 million persons from 1994-2000 found 128 cases of drug induced liver injury [2.4/100,000 person years]; 3 cases were attributed to cimetidine for an odds ratio of 2.0 compared to controls [n=5000], which was not statistically significant). 15206996
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; 103 cases identified as highly probable, probable or possible, one case attributed to ranitidine and one to omeprazole). 16165719
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Population based survey of 126 cases of acute liver injury due to drugs between 1993-1999 in Spain; 8 were attributed to ranitidine alone [incidence 5.1/100,000 person-years] and 5 to omeprazole alone [2.1/100,000]). 17539979
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 2 were attributed to ranitidine, none to cimetidine or omeprazole). 18955056
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children; no antiulcer medication was in the top 40 causes). 21039766
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India, but none of the cases were attributed to cimetidine or other antiulcer agents). 20648003
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked to antiulcer medications). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to cimetidine or other antiulcer medications). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17] and antituberculosis drugs [n=13]; no case was linked to an antiulcer agent or H2 blocker). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 6 cases were attributed to anti-ulcer medications, 3 to ranitidine and 3 to PPIs, but none to cimetidine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Cimetidine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cimetidine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cimetidine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cimetidine)